# Oregano

## OVERVIEW

### Introduction

Oregano is a perennial flowering plant the dried leaves and flowers of which are used as a spice and flavoring agent. In addition, oregano oils have been used in traditional medicine as therapy for a variety of conditions in respiratory diseases and parasitic and fungal infections. Oregano extracts have not been approved as therapy of any disease or condition but are available over-the-counter and are generally recognized as safe, have not been associated with serum enzyme elevations during therapy or implicated in cases of clinically apparent liver injury.

### Background

Oregano (Origanum vulgare) is a perennial flowering plant and member of the mint family (Lamiaceae) which is native to the Mediterranean area and Southwest Asia, extracts of which are used widely as a spice and food flavoring agent. In addition, oregano oil extracts have been used in traditional medicine, generally to treat respiratory disorders and infections such as colds, fever, cough, bronchitis, bacterial and fungal infections, parasites, and urinary tract infections. Oregano leaves and flowers contain more than 60 identified constituents including polyphenols, flavonoids, monoterpenoids, monoterpenes, and several volatile oils such a carvacrol, thymol, gamma terpinene, p-cymene and caryophyllene. The principal biologically active component of oregano oil is suspected to be carvacrol or thymol. Oregano has antimicrobial, antifungal, antiparasitic, antioxidant, and antineoplastic activities in vitro and in vivo, but these effects have not been demonstrated in humans, and the clinical significance of these actions has not been established. Oregano oil has not been approved as therapy of any disease or medical condition in the United States, but is available over-the-counter as a dietary supplement in multiple formulations including capsules and oil solutions which are advertised for boosting energy and general wellness. The typical recommended dose ranges widely based in part on the relative concentration of essential oils. Oregano oil is usually well tolerated but side effects of higher doses can include abdominal discomfort, heartburn, constipation or diarrhea, nausea and vomiting, dizziness, and headache. Rare adverse events include hypersensitivity reactions. Oregano in doses used as a dietary supplements is an abortifacient and should not be used during pregnancy or in women of childbearing age not using effective contraception.

### Hepatotoxicity

The effects of different oral doses of oregano on serum enzyme levels in humans has not been well defined, but in limited prospective studies, oregano has not been linked to serum aminotransferase elevations or clinically apparent liver injury. Despite widespread use as a culinary herb in spice and food flavoring as well as a dietary supplement, there have been no published reports of serum enzyme elevations or clinically apparent liver injury attributable to oregano oil.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which oregano extracts might cause liver injury is unknown.

### Outcome and Management

Hepatotoxicity from extracts of oregano has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Wild Marjoram, Winter Marjoram.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oregano – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/644.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Oregano | 8007-11-2 (https://pubchem.ncbi.nlm.nih.gov/substance/135332943) | Herbal | Not Applicable
Carvacrol | 499-75-2 | C10-H14-O*
Thymol | 89-83-8 | C10-H14-O*

* Structural isomers.

## ANNOTATED BIBLIOGRAPHY

References updated: 28 April 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not oregano).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of oregano).
Oregano. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 621-623. (Compilation of short monographs on herbal medications and dietary supplements).
Electronic Code of Federal Regulations. Title 21. Part 182 -- Substances Generally Recognized As Safe. Available at: https://www.accessdata.fda.gov/scripts/cdrh/cfdocs/cfcfr/CFRSearch.cfm?CFRPart=182 (Listing of agents generally recognized as safe by the FDA, lists culinary use of oregano as being safe).
Benito M, Jorro G, Morales C, Peláez A, Fernández A. (1996). Labiatae allergy: systemic reactions due to ingestion of oregano and thyme. Ann Allergy Asthma Immunol. (45 year old man with asthma had an immediate hypersensitivity reaction [rash, lip swelling, stridor, mild hypotension responding to epinephrine] in response to foods that contained oregano and then thyme, later tolerating the same foods without the spices and with positive skin prick tests and in vitro assays to multiple members of the mint family [Lamiaceae]).
Ciganda C, Laborde A. (2003). Herbal infusions used for induced abortion. J Toxicol Clin Toxicol. (Among 86 cases of herbal ingestion with abortive intent reported to the Uruguayan Poison Control Center over a 3 year period, all were within the first trimester [23 resulting in abortion, 6 fatal] and were attributed to a total of 30 different plant species, most frequently Ruta chalepensis [n=26, 13 with jaundice, 4 fatal], Lycopodium saururus [n=22], parsley [n=13], and a multiingredient product called “Carachipita” with pennyroyal, oregano, M. pinnatus, S. brasiliensis [n=13, 3 with jaundice, 1 fatal]).
Nurmi A, Mursu J, Nurmi T, Nyyssönen K, Alfthan G, Hiltunen R, Kaikkonen J, et al. (2006). Consumption of juice fortified with oregano extract markedly increases excretion of phenolic acids but lacks short- and long-term effects on lipid peroxidation in healthy nonsmoking men. J Agric Food Chem. (Among 45 healthy volunteers given daily mango-orange juice with or without a phenolic oregano extract [300 or 600 mg] daily for 4 weeks, the excretion of phenolic acids increased in those receiving the oregano extract but serum ALT, GGT and lipids levels as well as special biomarkers of lipid peroxidation did not change and were similar in the 3 groups).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list oregano among products associated with 5 or more reports).
Singletary K. (2010). Oregano: overview of the literature on health benefits. Nutrition Today. (Concise summary of the history of use of oregano in traditional medicine, the chemical constituents of oregano and the in vitro and in vivo evidence for its antioxidant, antimicrobial and antineoplastic activities).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not oregano).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not mention or list oregano).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention oregano).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to oregano).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss oregano).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of oregano).
Sharifi-Rad M, Varoni EM, Iriti M, Martorell M, Setzer WN, Del Mar Contreras M, Salehi B, et al. (2018). Carvacrol and human health: a comprehensive review. Phytother Res. (Review and discussion of the in vitro and in vivo studies demonstrating potent antioxidant, antimicrobial and antineoplastic activities of carvacrol, an aromatic volatile oil found in oregano and thyme mentions that “human trials of carvacrol are still lacking”).
Negri R, Trinchese G, Carbone F, Caprio MG, Stanzione G, di Scala C, Micillo T, et al. (2020). Randomised clinical trial: calorie restriction regimen with tomato juice supplementation ameliorates oxidative stress and preserves a proper Immune surveillance modulating mitochondrial bioenergetics of T-lymphocytes in obese children affected by non-alcoholic fatty liver disease (NAFLD). J Clin Med. (Among 61 obese children treated with a caloric restricted diet with or without an oral supplement of lycopine-rich tomato sauce, oregano and basil extract in a cross over design, addition of the supplement was associated with more weight loss and improvement in metabolic factors).
Cohen SM, Eisenbrand G, Fukushima S, Gooderham NJ, Guengerich FP, Hecht SS, Rietjens IMCM, et al. (2021). FEMA GRAS assessment of natural flavor complexes: Origanum oil, thyme oil and related phenol derivative-containing flavoring ingredients. Food Chem Toxicol. (Extensive reevaluation of the safety of phenol-derivative containing flavoring agents including oregano oil providing the basis for continuing to list it as a flavoring agent that is “generally recognized as safe” [GRAS]).
Balahbib A, El Omari N, Hachlafi NE, Lakhdar F, El Menyiy N, Salhi N, Mrabti HN, et al. (2021). Health beneficial and pharmacological properties of p-cymene. Food Chem Toxicol. (Extensive review of the in vitro and in vivo pharmacological activities of p-cymene, a monoterpene found in many medicinal plants including oregano; human studies of its safety and efficacy are lacking).
Maral H, Ulupınar S, Türk Baydır A, Özbay S, Altınkaynak K, Şebin E, Şiktar E, et al. (2021). Effect of Origanum dubium, Origanum vulgare subsp. hirtum, and Lavandula angustifolia essential oils on lipid profiles and liver biomarkers in athletes. Z Naturforsch C J Biosci. (Among 34 athletes treated with essential oils from 3 plants of the mint family, including oregano, or placebo for 4 weeks, treatment led to a significant decrease in LDL cholesterol and rise in HDL cholesterol in those receiving oregano oil).
Bajagai YS, Radovanovic A, Steel JC, Stanley D. (2021). The effects of continual consumption of Origanum vulgare on liver transcriptomics. Animals (Basel). (Among 24 chicks fed with or without oregano oil supplementation for 42 days, body weight was similar in the two groups and liver histology was normal, but transcriptomics analysis demonstrated major inhibition of aldosterone and dihydrotestosterone pathways in those receiving oregano oil).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; oregano was not listed among the 79 implicated products).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while oregano is not mentioned).

## OTHER REFERENCE LINKS

1 Recent References on Oregano: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Oregano+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Oregano: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oregano)